# Fentanyl

## OVERVIEW

### Introduction

Fentanyl is a fully synthetic opioid that is more potent that morphine and is commonly used for management of severe pain and as an adjunct to general anesthesia. Alfentanil, remifentanil and sufentanil are phenylpiperidine analogues of fentanyl and have a similar spectrum of activity, but differ in their pharmacokinetics, potency and routes of administration, and are used only in anesthesia. None of the phenylpiperidine opioids have been implicated in causing serum enzyme elevations or clinically apparent liver injury.

### Background

Fentanyl (fen’ tan il) is a synthetic phenylpiperidine which shares similar pain relieving activities with morphine, but is 50 to 100 times more potent. Like morphine, fentanyl is an agonist for the µ type opiate receptors which are found in the central nervous system but also on heart, lung, vascular and intestinal cells. Fentanyl has a rapid onset and short duration of action, making it particularly effective in anesthesia induction as well as maintenance. Fentanyl was approved for use in general anesthesia in the United States in 1968 and is still widely used in anesthesia practice. With the development of transdermal and buccal formulations of fentanyl, it was approved for use in pain management and has become the most widely used synthetic opioid in clinical practice. Current indications are as an adjunct to general anesthesia (intravenous, epidural or intrathecal) and for management of moderate-to-severe pain that is not responsive to nonopiate analgesics. Fentanyl is available in multiple formulations, including solutions for injection in multiple concentrations for anesthesia and acute pain management, and as transdermal patches, oral tablets and lozenges and nasal sprays for management of chronic pain. Fentanyl is available generically and under commercial names including Sublimaze (solution for injection), Duragesic and Ionsys (transdermal patches), Actiq and Fentora (lollipop and tablets for transmucosal delivery) in multiple dose formulations. Side effects of fentanyl resemble those of other opioids and include sedation, respiratory depression, confusion, euphoria, agitation, headache, dizziness, constipation, diarrhea, abdominal bloating, nausea and vomiting. Fentanyl and its congeners are controlled substances and classified as Schedule II drugs, indicating that they have medical usefulness, but also a high potential for physical and psychological dependency and abuse. Indeed, deaths have been reported due to fentanyl patches and transbuccal formulations either from inadvertent overdose, accidental ingestion (by children for instance) or abuse.

Alfentanil (al fen’ ta nil) is a structural analogue of fentanyl, which has a very short onset of action (5 to 10 minutes) and is approved for use as an adjunct to general anesthesia. Alfentanil is available as a solution for intravenous use in anesthesia generically and under the trade name Alfenta. It has similar adverse effects as fentanyl, but is not used for chronic pain management and should be used only by medical personnel trained in the use of intravenous anesthesia.

Remifentanil (rem” i fen’ ta nil) is a structural analogue of fentanyl, but has a very short onset and duration of action with a rapid dissipation of activity even after prolonged infusions. Remifentanil is available as a solution under the brand name Ultiva for intravenous use in anesthesia. It has similar adverse effects as fentanyl, but is not used for chronic pain management and should be used only by medical personnel trained in the use of intravenous anesthesia.

Sufentanil (soo fen’ ta nil) is a structural analogue of fentanyl, which is 10 times more potent and is generally reserved for anesthesia in patients with opioid tolerance or opioid dependence. It is potent enough to overcome the actions of partial opiate antagonists such as buprenorphine. Sufentanil was approved for use in the United States in 1984. Sufentanil is available as a solution for intravenous and epidural use in anesthesia generically and under the brand name Sufenta. It has similar adverse effects as fentanyl, but is not used for chronic pain management and should be used only by medical personnel trained in the use of intravenous anesthesia.

### Hepatotoxicity

Although fentanyl has many serious side effects and has been implicated in deaths from overdose and inadvertent use, it has not been linked to cases of clinically apparent liver injury. In large clinical trials, chronic fentanyl therapy for pain has not been associated with serum enzyme elevations or cases of hepatotoxicity. The dangers of fentanyl are largely from respiratory depression rather than liver injury. Fentanyl and its analogues are metabolized in the liver largely by the P450 enzyme system, and plasma levels are affected by inhibitors (yielding higher levels and increasing toxicity) and inducers (yielding lower levels and reduced efficacy) of CYP 3A4.

Likelihood score: E (all four are unlikely cases of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of fentanyl and its congeners are given in the Overview section of the Opioids.

Drug Class: Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fentanyl – Generic, Duragesic®, Sublimaze®

Alfentanil – Generic, Alfenta®

Remifentanil – Ultiva®

Sufentanil – Generic, Sufenta®

DRUG CLASS

Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fentanyl)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Fentanyl | 437-38-7 | C22-H28-N2-O | Fentanyl Chemical Structure
Alfentanil | 71195-58-9 | C21-H32-N6-O3 | Alfentanil Chemical Structure
Remifentanil | 132875-61-7 | C20-H28-N2-O5 | Remifentanil Chemical Structure
Sufentanil | 56030-54-7 | C22-H30-N2-O2-S | Sufentanil Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Fentanyl: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Fentanyl+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Fentanyl: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fentanyl)